# Penicillins (1st Generation)

## OVERVIEW

The natural or "first generation" penicillins are bactericidal antibiotics naturally derived from the mold, Penicillium chrysogenum. Their basic structure includes a thiazolidine ring connected to a beta-lactam ring with a variable side chain. Penicillins bind to bacterial proteins and inhibit synthesis of the bacterial cell wall, causing cell lysis particularly in rapidly growing organisms. Bacterial resistance to penicillin is usually mediated by beta-lactamase, an enzyme which destroys the beta-lactam ring of penicillin, rendering it inactive. Penicillin was introduced into medicine in the 1940’s and ushered in the modern era of antibiotic therapy, ending the dominance of many diseases that had been major causes of morbidity and mortality. At present, several first generation penicillins are available in the United States: the benzathine, potassium, procaine and sodium salts of penicillin G and the orally available penicillin V potassium. These agents are discussed together as they are rare causes of hepatotoxicity and can be considered similar enough to be grouped together.

Drug Class: Antiinfective Agents

The following are links to each drug record:

- Penicillin G
- Penicillin G Benzathine
- Penicillin V

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Penicillin G (Benzylpenicillin) | 61-33-6 | C16-H18-N2-O4-S
Penicillin G Sodium | 69-57-8 | C16-H18-N2-O4-S
Penicillin G Potassium | 113-98-4 | C16-H18-N2-O4-S.K
Penicillin V | 87-08-1 | C16-H18-N2-O5-S
Penicillin V Potassium | 132-98-9 | C16-H17-K-N2-O5-S C16-H17-N2-O5-S.K C16-H18-N2-O5-S.K

## OTHER REFERENCE LINKS

1 Recent References on First Generation Penicillins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(penicillin+V/AE+%5BMH:noexp%5D+OR+penicillin+G/AE+%5BMH:noexp%5D+)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on First Generation Penicillins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Penicillin+V+OR+Penicillin+G)